# Macrolide Antibiotics

## OVERVIEW

The macrolides are bacteriostatic antibiotics with a broad spectrum of activity against many gram-positive bacteria. Currently available macrolides are well tolerated, orally available and widely used to treat mild-to-moderate infections. Several macrolide antibiotics have been linked to liver injury.

Five macrolide antibiotics are currently available for use in the United States: erythromycin, clarithromycin, azithromycin, fidaxomicin and telithromycin, the latter being a related ketolide. Erythromycin was initially isolated in 1952 from Streptomyces erythreus; the other macrolide antibiotics are semisynthetic derivatives. The five macrolide antibiotics have a similar range of activities, being bacteriostatic against many strains of streptococci, staphylococci, clostridia, corynebacteria, listeria, haemophilus sp., moxicella, and Neisseria meningitidis. Clarithromycin and azithromycin are more active than erythromycin against several gram negative bacteria as well as Mycoplasma pneumonia, Helicobacter pylori, Toxoplasma gondii, cryptosporidia and several atypical mycobacteria. Fidaxomicin is not absorbed orally and is used in ten day oral courses to treat Clostridium difficile associated diarrhea. Macrolide antibiotics act by inhibiting protein synthesis of bacteria by binding to the 50S ribosomal element. Resistance occurs by several mechanisms.

Aa low rate of asymptomatic elevation in serum aminotransferase levels that can occur with any of the four orally absorbed macrolide antibiotics, in rates reported to be 1% to 5% of treated patients (depending upon the duration of treatment and intensity of monitoring). These elevations are generally mild-to-moderate in degree, asymptomatic and self-limited and transient in course, rarely requiring dose modification or discontinuation.

More important is clinically apparent liver injury from macrolide antibiotics which has been described for all four of the orally absorbed agents. The liver injury is typically a self-limited cholestatic hepatitis arising within 1 to 3 weeks of starting therapy. Symptoms include fatigue, dark urine and jaundice, often with right upper quadrant pain and fever. The injury is usually self-limited and benign, but in some instances there is prolonged cholestasis and persistence of liver test abnormalities beyond 6 months. Liver histology in these cases generally shows vanishing bile duct syndrome, or at least, some degree of bile ducts loss. A second form of clinically apparent hepatotoxicity from the macrolide antibiotics is an acute hepatocellular injury that usually arises within days of starting therapy, often with re-exposure. This hepatocellular injury with jaundice can lead to acute liver failure and has an appreciable mortality (either death or need for emergent liver transplantation). This hepatocellular pattern occurs most commonly with telithromycin, but is also described with azithromycin and less commonly with claritheromycin and erythromycin.

Fidaxomicin has little systemic absorption and has not been linked to episodes of clinically apparent liver injury. There is likely to be some degree of cross sensitivity to the hepatic injury among the various macrolide antibiotics, but this has not been well defined.

Drug Class: Antiinfective Agents

The following links are to individual drug records.

- Azithromycin
- Clarithromycin
- Erythromycin
- Fidaxomicin
- Telithromycin

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2017

Zimmerman HJ. Erythromycins. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 594-5. (Expert review of erythromycin induced liver injury published in 1999; erythromycin has been linked most closely with cholestatic hepatitis with onset of 10-20 days on initial exposure and within a week on repeated exposures, presenting with abdominal pain [75%], fever [50%], jaundice [50%], eosinophilia [60%] and pruritus [25%], usually with a self-limiting and benign course).
Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic induced liver injury mentions liver injury attributed to erythromycin, azithromycin and clarithromycin, and that telithromycin has been linked to several instances of severe acute liver injury, some of which have been fatal).
MacDougall C, Chambers HF. Macrolides and ketolides. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1529-34. (Textbook of pharmacology and therapeutics).
Braun P. Hepatotoxicity of erythromycin. J Infect Dis 1969; 119: 300-6. (Thorough review of literature on hepatotoxicity of macrolides up to 1969; by then, 45 published cases reported from erythromycin estolate [none with stearate] presenting within 1-3 weeks with jaundice [67%], abdominal pain, nausea and fever [~50%], as well as eosinophilia [62%], elevations in ALT [100%: average 338 U/L] and Alk P [51%]; 13 rechallenged, invariably followed by rapid recurrence, often severe). 4888905
The erythromycins. A further report from the Australian Drug Evaluation Committee. Med J Aust 1973; 2: 192-3. (As of May 1973, 113 Australian cases of jaundice related to erythromycin [all with estolate] have been reported including patients of all ages, mostly within 14 days of starting drug, but some >21, and injury usually lasting less than 28 days, no deaths). 4741351
Zafrani ES, Ishak KG, Rudzki C. Cholestatic and hepatocellular injury associated with erythromycin esters: report of nine cases. Dig Dis Sci 1979; 24: 385-96. (Classic review of histology from 9 cases of erythromycin liver injury from files of the Armed Forces Institute of Pathology, mostly cholestatic or mixed enzyme pattern, all self-limited, ALT 128-560 U/L, Alk P 2-12 times ULN, bilirubin 2.1-12.0 mg/dL; histology showed cholestasis and hepatocellular injury). 456225
Pessayre D, Larrey D, Funck-Brentano C, Benhamou JP. Drug interactions and hepatitis produced by some macrolide antibiotics. J Antimicrob Chemother 1985; 16 Suppl A: 181-94. (Review of hepatic effects of macrolides including 55 cases of hepatitis from erythromycin estolate, 10 from ethylsuccinate, and 3 from propionate; “mixed” enzyme pattern was common, fever in 59%, eosinophilia in 45%, “outcome is always favorable”). 3877043
Bojarska-Dahlig H. Hepatotoxicity of macrolide antibiotics. J Antimicrob Chemother 1990; 25: 475-7. (Discussion of relative rates of liver injury in rats based upon molecular weight and erythromycin equivalents). 2338425
Carson JL, Strom BL, Duff A, Gupta A, Shaw M, Lundin FE, Das Kl. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (In Medicaid records between 1980-87, 107 patients were hospitalized for acute hepatitis of unknown cause, 5 [4.7%] of whom had received erythromycins compared to 0.9% of controls; no case received estolate form). 8363168
Derby LE, Jick H, Henry DA, Dean AD. Erythromycin-associated cholestatic hepatitis. Med J Aust 1993; 158: 600-2. (Retrospective cohort study of 366,064 people who received erythromycin in UK database, found 13 cases of cholestatic hepatitis of uncertain cause within 45 days of prescription: risk=3.6/100,000 similar for ethylsuccinate and base preparations [estolate and stearate rarely used]: risk increased with age, independent of sex). 8479375
Pérez Gutthann S, García Rodríguez LA. The increased risk of hospitalizations for acute liver injury in a population with exposure to multiple drugs. Epidemiology 1993; 4: 496-501. (Case control study from Canadian Health Plan records between 1982-6, risk of hospitalization for liver injury was 1/100,000 for NSAIDs and 14/100,000 for erythromycin estolate [no case related to other types of erythromycin] and risk increased if multiple known causes of hepatotoxicity were used). 8268277
Periti P, Mazzei T, Mini E, Novelli A. Adverse effects of macrolide antibacterials. Drug Saf 1993; 9: 346-64. (Extensive review of literature on adverse events reported with macrolide antibiotics). 8280403
Hautekeete ML. Hepatotoxicity of antibiotics. Acta Gastroenterol Belg 1995; 58: 290-6. (Review of hepatotoxicity associated with antibiotics including the erythromycins, well known causes of cholestatic hepatitis). 7491842
von Rosensteil NA, Adam D. Macrolide antibacterials. Drug interactions of clinical significance. Drug Saf 1995; 13: 105-22. 7576262
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Erythromycin ranked first as a cause of liver adverse drug reaction in New Zealand from 1974 to 1995, accounting for ~12% of cases). 8816722
Viluksela M, Vainio PJ, Tuominen RK. Cytotoxicity of macrolide antibiotics in a cultured human liver cell line. J Antimicrob Chemother 1996; 38: 465-73. (In vitro study of cytotoxicity of macrolides). 8889721
Vial T, Biour M, Descotes J, Trepo C. Antibiotic-associated hepatitis: update from 1990. Ann Pharmacother 1997; 31: 204-20. (Extensive review including discussion of macrolides [erythromycin, clarithromycin and azithromycin], ALT elevations in 0.4-1.2% of treated patients, but similar rates found in placebo controls; rare instances of cholestatic hepatitis have been reported with all three macrolides). 9034423
Chitturi S, Farrell GC. Drug-induced cholestasis. Semin Gastrointest Dis 2001; 12: 113-24. (Review of cholestatic forms of drug induced liver disease with a case report of prolonged jaundice and pruritus starting 8 weeks after a 1-week course of erythromycin base). 11352118
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (All fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases, only one due to erythromycin). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Among 4690 reports of drug induced liver injury with fatal outcome reported to WHO, clarithromycin was among the top 20 agents implicated [51 cases]). 16054882
Chang CY, Schiano TD. Drug hepatotoxicity. Aliment Pharmacol Ther 2007; 25: 1135-51. (Review article summarizing large cohort studies in which erythromycin or the macrolides were often among the most common causes of liver injury). 17451560
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 5 cases were attributed to telithromycin and 3 to azithromycin as single agents, but none to erythromycin or clarithromycin). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children included 63 cases attributed to azithromycin, 60 to erythromycin and 35 to clarithromycin). 21039766
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review; the macrolide antibiotics may cause cholestatic hepatitis at an estimated rate of 3.6 for erythromycin, 3.8 for clarithromycin, and 5.5 cases per 100,000 prescriptions for telithromycin, compared to 10 for sulfonamides and 2000 per 100,000 for isoniazid). 20107858
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but only one due to macrolides [clarithromycin] and none to telithromycin). 20949552
Andrade RJ, Tulkens PM. Hepatic safety of antibiotics used in primary care. J Antimicrob Chemother 2011; 66: 1431-46. (Review: short description of the clinical and histologic features of hepatotoxicity associated with erythromycin, clarithromycin, azithromycin and telithromycin). 21586591
Gagne JJ, Glynn RJ, Rassen JA, Walker AM, Daniel GW, Sridhar G, Schneeweiss S. Active safety monitoring of newly marketed medications in a distributed data network: application of a semi-automated monitoring system. Clin Pharmacol Ther 2012; 92: 80-6. (Description of results of a semiautomated, sequential propensity score with a matched cohort approach for drug safety monitoring based upon electronic databases; among 106,658 new users of telithromycin and a similar number of users of azithromycin identified over a 5 year period, 41 cases of hepatitis were found, 23 due to telithromycin for a risk rate of 2 per 10,000 users, not appreciably greater than with azithromycin). 22588606
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 Feb 15. [Epub ahead of print] (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period including 28 due to an antibiotic, but none were attributed to azithromycin or other macrolides). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, only one was attributed to a macrolide antibiotic: clarithromycin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 233 [36%] were attributed to antibiotics including 29 [3.2%] from macrolide anitbiotics: 18 due to azithromycin, 2 clarithromycin, 2 erythromycin and 7 telithromycin). 25754159
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a health care database of 429,772 children in Italy and the Netherlands followed between 2008 and 2010, 938 cases of liver injury of uncertain cause were identified, the rate being higher in those with current use of antibiotics [12% vs 3.6%] for an adjusted odds rate ratio [aOR] of 3.2; specific antibiotics most commonly implicated were fluoroquinolones [19.0], cephalosporins [4.5], macrolides [3.5] and penicillins [2.6], and a specific aOR for azithromycin of 2.4). 28025733
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 2 cases attributed to azithromycin both of whom developed evidence for chronic liver injury suggestive of vanishing bile duct syndrome). 27981596

## OTHER REFERENCE LINKS

1. Recent References on Macrolide Antibiotics: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(macrolides/AE+AND+anti-bacterial+agents/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222007/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Macrolide Antibiotics: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=macrolide+antibiotics)